# Pregabalin

## OVERVIEW

### Introduction

Pregabalin is an inhibitor of neuronal activity used for therapy of painful neuropathy and as an anticonvulsant. Therapy with pregabalin is not associated with serum aminotransferase elevations, and clinically apparent liver injury from pregabalin has been reported but appears to be quite rare.

### Background

Pregabalin (pre gab' a lin) is a structural analogue of gamma-aminobutyric acid (GABA) but is novel in its activity, having no effects on GABA-A or GABA-B receptors. Instead, the neuronal activity of pregabalin appears to be mediated by its binding to the alpha-2-delta subunit of the presynaptic voltage-gated calcium channel which leads to a decrease in release of neuroexcitatory neurotransmitters by hyperexcited neurons. Pregabalin has been shown to be effective in reducing neuropathic pain from diabetic and postherpetic neuropathy and is an effective anticonvulsant. Pregabalin was approved for use in the United States in 2004. Current indications include diabetic and post-herpetic neuropathy and as adjunctive therapy of partial onset seizures. Pregabalin is also used for fibromyalgia and off-label for generalized anxiety disorders and migraine. Pregabalin is available in capsules in varying concentrations from 25 to 300 mg under the brand name of Lyrica. The recommended initial dose for neuropathic pain is 50 to 75 mg two to three times daily, the maximum dose being 300 mg daily. Higher doses are used in treating seizures. The dose should be increased and tapered gradually. The most common side effects of pregabalin are dose related and include peripheral edema, weight gain, dizziness, somnolence, confusion, headache, blurred vision, tremor and ataxia. Rare but potentially severe adverse events include depression, suicidal ideation and behaviors, angioedema, and hypersensitivity reactions.

### Hepatotoxicity

Limited data is available on the hepatotoxicity of pregabalin. In prelicensure clinical trials in diabetic neuropathy and epilepsy, therapy with pregabalin was not associated with an increased frequency of serum aminotransferase elevations or liver toxicity. Since its approval and more wide scale use, however, pregabalin has been linked to rare instances of clinically apparent liver injury. Most cases were mild and frequently without jaundice. The latency to onset of injury was short, symptoms of liver injury arising within 3 to 14 days. Both cholestatic and hepatocellular patterns of injury have been reported. Signs of hypersensitivity (fever, rash, eosinophilia) and autoimmunity were not present. Some cases have been severe and associated with marked jaundice and prolongation of the prothrombin time, but all cases ultimately resolved after the medication was stopped without evidence of residual injury.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The low rate of significant hepatotoxicity from pregabalin may be due to its minimal hepatic metabolism and rapid urinary excretion. The injury is clearly idiosyncratic and either immunologic or metabolic causes are possible.

### Outcome and Management

The case reports of hepatic injury due to pregabalin were followed by complete recovery without evidence of residual or chronic injury. There is no information about cross reactivity with other compounds having similar structure (gabapentin).

Drug Class: Anticonvulsants

## CASE REPORT

### Case 1. Mild cholestatic hepatitis attributed to pregabalin therapy.(1)

A 61 year old man underwent laminectomy for spinal stenosis and was started on pregabalin 2 weeks later. Within 2 days he developed dizziness, blurred vision, somnolence and fatigue, which worsened when the dose was increased from 75 to 150 mg/day one week later. Because of persistence of symptoms, blood tests were taken 11 days after starting therapy which revealed moderate enzyme elevations (Table). The patient had a history of hypertension and gout for which he took amlodipine (5 mg/day), candesartan (16 mg/day) and allopurinol (100 mg/day) chronically. Before the laminectomy, serum enzymes were tested and were normal. After surgery, he received metamizole (an NSAID not available in the US) for five days. Physical examination showed no jaundice, rash or signs of chronic liver disease. Tests for hepatitis A, B, C, D, and E, for HIV and for autoantibodies were negative. Abdominal ultrasound and MRCP were normal. Pregabalin was stopped and all symptoms except for mild fatigue, resolved rapidly. Reintroduction of pregabalin a few days later led to an immediate return of symptoms, but blood tests were not taken during the rechallenge. The abnormal enzyme values rapidly improved once pregabalin was stopped and were normal two months later.

#### Key Points

Medication: | Pregabalin (75→150 mg daily)
Pattern: | Mixed (R=2.1)
Severity: | 1+ (enzyme elevations without jaundice)
Latency: | 2 days to onset of symptoms, 11 days to laboratory abnormalities
Recovery: | Rapid (2 to 8 weeks)
Other medications: | Amlodipine, candesartan, and allopurinol chronically; metamizole for 5 days 3 weeks before onset.

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | Normal | Normal | Normal | Preoperative evaluation
0 | Pregabalin started: 75 mg/day increasing to 150 mg/day one week later
11 days | 0 | 307 | 476 | 1.7 | GGT 1546 U/L
22 days | 10 days | 37 | 174 | 1.0 | GGT 542 U/L
11 weeks | 10 weeks | 32 | 125 | 0.9 | GGT 44 U/L
Normal Values | | <40 | <130 | <1.2

#### Comment

Other causes of acute liver disease were excluded. The rechallenge was somewhat convincing, but the role of pregabalin in causing liver injury was not completely proven because of the lack of testing immediately before and after the two day rechallenge (on days 13-14 after starting). Based on the “R” value, the pattern of enzyme elevations was “mixed,” but the subsequent values and GGT elevations suggest that the injury was cholestatic. Most published cases of liver injury attributed to pregabalin have been marked by a short latency (3 to 14 days) and a rapidly resolving, self-limiting course.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Pregabalin – Generic, Lyrica®

DRUG CLASS

Anticonvulsants

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Pregabalin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Pregabalin | 148553-50-8 | C8-H17-N-O2

## CITED REFERENCE

1 Crespo Pérez L, Moreira Vicente V, Manzano Fernández R, García Aguilera XA. (2008). Med Clin (Barc).

## ANNOTATED BIBLIOGRAPHY

References updated: 30 July 2020

Abbreviations used: DRESS, drug rash with eosinophilia and systemic symptoms; SJS/TEN, Stevens-Johnson syndrome and toxic epidermal necrolysis.

Zimmerman HJ. Anticonvulsants. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 498-516. (Expert review of liver injury due to anticonvulsants published in 1999, before the clinical availability of pregabalin which is not discussed).
Pirmohamed M, Leeder SJ. Anticonvulsant agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp 423-41. (Review of anticonvulsant induced liver injury does not specifically discuss pregabalin).
Smith MD, Metcalf CS, Wilcox KS. Pharmacology of the epilepsies. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 303-26. (Textbook of pharmacology and therapeutics).
Huckle R. (2004). Pregabalin (Pfizer). Curr Opin Investig Drugs. (History of development of pregabalin and summary of information on mechanisms of action, pharmacology, pharmacokinetics, and clinical data supporting indications; no information on liver adverse events).
Ben-Menachem E. (2004). Pregabalin pharmacology and its relevance to clinical practice. Epilepsia. (Summary of pharmacology and pharmacokinetics of pregabalin; it has no hepatic metabolism and does not induce P450 enzymes).
Kavoussi R. (2006). Pregabalin: From molecule to medicine. Eur Neuropsychopharmacol. (Summary of mechanism of action and clinical experience with pregabalin in generalized anxiety disorder; no mention of hepatic adverse events).
Tassone DM, Boyce E, Guyer J, Nuzum D. (2007). Pregabalin: a novel gamma-aminobutyric acid analogue in the treatment of neuropathic pain, partial-onset seizures, and anxiety disorders. Clin Ther. (Review of efficacy and safety of pregabalin; major side effects were CNS related including dizziness, somnolence, headache, and ataxia, also edema and weight gain; withdrawal symptoms included anxiety, irritability and nervousness: “…there were no significant differences in changes in blood chemistry or hematology tests…”).
Crespo Pérez L, Moreira Vicente V, Manzano Fernández R, García Aguilera XA. (2008). Med Clin (Barc). (61 year old man with neuropathic pain after laminectomy developed symptoms of dizziness and fatigue within 2 days, and liver test abnormalities at 11 days after starting pregabalin [bilirubin 1.2 mg/dL, ALT 307 U/L, Alk P 476 U/L], symptoms recurring with rechallenge, and all signs of injury resolving within 2 months of stopping: Case 1).
Einarsdottir S, Björnsson E. (2008). Pregabalin as a probable cause of acute liver injury. Eur J Gastroenterol Hepatol. (61 year old man developed nausea followed by jaundice 8 days after starting pregabalin [bilirubin 10.7 mg/dL, ALT 35 times ULN, INR 3.8], resolving completely within 24 weeks).
Freeman R, Durso-Decruz E, Emir B. (2008). Efficacy, safety, and tolerability of pregabalin treatment for painful diabetic peripheral neuropathy: findings from seven randomized, controlled trials across a range of doses. Diabetes Care. (Pooled data from 7 trials of pregabalin given for 5-13 weeks vs placebo in 1510 patients; common side effects were edema, weight gain, dizziness and somnolence with “…no clinically meaningful changes in laboratory values from baseline.”).
Stein DJ, Baldwin DS, Baldinetti F, Mandel F. (2008). Efficacy of pregabalin in depressive symptoms associated with generalized anxiety disorder: a pooled analysis of 6 studies. Eur Neuropsychopharmacol. (Pooled analysis in >1000 patients with generalized anxiety disorder showed improvement with higher doses, but provided no information on tolerance or side effects).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, none were linked to pregabalin).
[Hepatic adverse effects of pregabalin (Lyrica)]. Lakartidningen 2010; 107(4): 194. Swedish.
Johannessen Landmark C, Patsalos PN. (2010). Drug interactions involving the new second- and third-generation antiepileptic drugs. Expert Rev Neurother. (Review of drug-drug interactions; pregabalin has not been implicated in clinical significant drug interactions with other major anticonvulsants).
Doğan S, Ozberk S, Yurci A. (2011). Pregabalin-induced hepatotoxicity. Eur J Gastroenterol Hepatol. (28 year old woman developed jaundice 4 months after starting pregabalin [bilirubin 16.3 mg/dL, ALT 26 times ULN, INR 1.91], resolving within 2 months of stopping).
Sendra JM, Junyent TT, Pellicer MJ. (2011). Pregabalin-induced hepatotoxicity. Ann Pharmacother. (59 year old man developed serum enzyme elevations 14 days after starting pregabalin [bilirubin 1.3 mg/dL, ALT 1582 U/L, Alk P 488 U/L], resolving in 4 months; patient had preexisting abnormalities and also received levofloxacin).
Zaccara G, Gangemi P, Perucca P, Specchio L. (2011). The adverse event profile of pregabalin: a systematic review and meta-analysis of randomized controlled trials. Epilepsia. (Analysis of 38 double-blind trials of pregabalin identified 20 adverse events that were more common with pregabalin than comparator arms and were mostly dizziness, vertigo, ataxia, diplopia, tremor, somnolence and confusion; even in non-frequently mentioned side effects, ALT elevations and hepatotoxicity were not listed).
Toth C. (2012). Drug safety evaluation of pregabalin. Expert Opin Drug Saf. (Review of structure, mechanism of action, pharmacokinetics, clinical uses and safety of pregabalin; common side effects include dizziness, sedation, dry mouth, weight gain and edema, rash and hypersensitivity reactions are rare; no mention of hepatotoxicity or ALT changes during therapy).
(2013). Drugs for epilepsy. Treat Guidel Med Lett. (Concise review of the drugs of choice for epilepsy; pregabalin is listed as an alternate drug of choice for partial onset seizures; side effects include somnolence, dizziness, ataxia, confusion, weight gain, dry mouth, blurred vision and edema; ALT elevations and liver injury are not mentioned).
Bamanikar A, Dhobale S, Lokwani S. (2013). Pregabalin hypersensitivity in a patient treated for postherpetic neuralgia. Indian J Pharmacol. (40 year old man developed fever, rash and facial swelling 2 weeks after starting pregabalin for post-herpetic neuralgia [bilirubin normal, ALT 250 U/L, Alk P normal], resolving on oral prednisolone and within a few months of stopping pregabalin).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, one of which was attributed to gabapentin but none to pregabalin ).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, 7 [4%] of which were attributed to anticonvulsants including phenytoin, carbamazepine and valproate but not pregabalin).
Devarbhavi H, Andrade RJ. (2014). Drug-induced liver injury due to antimicrobials, central nervous system agents, and nonsteroidal anti-inflammatory drugs. Semin Liver Dis. (Review of drug induced liver injury caused by several drug classes including antiepileptics, which account for 2-11% of all cases in various registries; a common presentation was with DRESS particularly with the older agents such as carbamazepine, phenytoin and phenobarbital and often associated with reactivation of human herpes virus 6 or 7).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 40 [4.5%] were due to anticonvulsants including 3 attributed to gabapentin but only one to pregabalin; a 44 year old woman developed nausea followed by jaundice a week after starting pregabalin for peripheral neuropathy [bilirubin 16.9 mg/dL, ALT 229 U/L, Alk P 116 U/L], resolving slowly with stopping, but taking several other potential hepatotoxic agents such as mercaptopurine and simvastatin).
Vidaurre J, Gedela S, Yarosz S. (2017). Antiepileptic drugs and liver disease. Pediatr Neurol. (Review of the use of anticonvulsants in patients with liver disease recommends use of agents that have little hepatic metabolism such as levetiracetam, lacosamide, topiramate, gabapentin and pregabalin, levetiracetam being an "ideal" first line therapy for patients with liver disease because of its safety and lack of pharmacokinetic interactions).
(2017). Drugs for epilepsy. Med Lett Drugs Ther. (Concise review of the drugs available for therapy of epilepsy lists pregabalin as an adjunctive treatment for partial seizures similar in action and efficacy to gabapentin, its most common adverse events being somnolence, dizziness, ataxia, dry mouth, blurred vision, confusion, edema, weight gain and myoclonus; no mention of ALT elevations or hepatotoxicity).
Borrelli EP, Lee EY, Descoteaux AM, Kogut SJ, Caffrey AR. (2018). Stevens-Johnson syndrome and toxic epidermal necrolysis with antiepileptic drugs: An analysis of the US Food and Drug Administration Adverse Event Reporting System. Epilepsia. (Review of adverse event reports to the FDA between 2014 and 2018 identified ~2.9 million reports, 1034 for SJS/TEN, the most common class of drugs being anticonvulsants with 17 of 34 having at least one report, those most frequently linked being lamotrigine [n=106], carbamazepine [22], levetiracetam [14], phenytoin [14], valproate [9], clonazepam [8], zonisamide [7], gabapentin [4] and pregabalin [4]; no mention of accompanying liver injury or whether attribution was as a single agent or one of several).
Cano-Paniagua A, Amariles P, Angulo N, Restrepo-Garay M. (2019). Epidemiology of drug-induced liver injury in a University Hospital from Colombia: Updated RUCAM being used for prospective causality assessment. Ann Hepatol. (Among 286 patients with liver test abnormalities seen in a single hospital in Colombia over a 1 year period, 17 were diagnosed with drug induced liver injury, the most common cause being antituberculosis therapy [n=6] followed by anticonvulsants [n=3, 1 each due to phenytoin, gabapentin and valproate]).
(2014). Gabapentin and pregabalin: hepatic and haematological toxicity. Prescrire Int. (Among adverse event reports to a French pharmacovigilance registry between 1995 and 2010, there were 90 reports of liver injury attributed to gabapentin, 37 described as hepatitis and 1 with a fatal outcome; and 32 reports of liver injury attributed to pregabalin of which 2 were fatal; no details given).
Kowar M, Friedrich C, Jacobs AH. (2015). Pregabalin als seltene Ursache einer Hepatopathie. Dtsch Med Wochenschr. (76 year old woman developed jaundice 15 days after starting pregabalin for back pain [bilirubin 6.0 mg/dL, ALT 2030 U/L, Alk P 650 U/L], with recovery 1-3 months after stopping).
Düzenli T, Ata E, Kösem M, Bayram Çarli A. (2017). Pregabaline as a rare cause of hepatotoxicity. Pain Med. (78 year old woman with painful neuropathy developed fatigue with a few days of starting pregabalin [bilirubin 0.6 mg/dL, ALT 701 U/L, Alk P 260 U/L], with rapid improvement on stopping).
(2018). Nonopioid drugs for pain. Med Lett Drugs Ther. (Concise review of nonopioid drugs that are used for pain, mentions that pregabalin is approved for use in post-herpetic and diabetic neuropathy as well as for fibromyalgia; no mention of hepatic adverse events).
Markman J, Resnick M, Greenberg S, Katz N, Yang R, Scavone J, Whalen E, et al. (2018). Efficacy of pregabalin in post-traumatic peripheral neuropathic pain: a randomized, double-blind, placebo-controlled phase 3 trial. J Neurol. (Among 539 adults with post-traumatic neuropathic pain treated for 15 weeks with pregabalin or placebo, there were no differences in improvements in pain scores between the two groups while adverse events more common with pregabalin were dizziness [15% vs 4%] and somnolence [10% vs 3%]; no mention of ALT elevations or hepatotoxicity).
Salehifar E, Janbabaei G, Hendouei N, Alipour A, Tabrizi N, Avan R. (2020). Comparison of the efficacy and safety of pregabalin and duloxetine in taxane-induced sensory neuropathy: a randomized controlled trial. Clin Drug Investig. (Among 82 patients with post-taxane chemotherapy neuropathy treated with pregabalin or duloxetine for 6 weeks, response rates were 93% for pregabalin vs 38% for duloxetine and adverse events were mild-to-moderate, dizziness and somnolence more common with pregabalin, nausea and vomiting with duloxetine; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Pregabalin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(pregabalin+AND+gamma-Aminobutyric+Acid/AE)+AND+Human%5BMH%5D+AND+(%20drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/11/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Pregabalin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=pregabalin)